# Guselkumab

## OVERVIEW

### Introduction

Guselkumab is human monoclonal antibody to interleukin-23 and is used to treat severe psoriasis. Guselkumab is associated with a low rate of transient and asymptomatic serum enzyme elevations during therapy, but has not been linked to cases of idiosyncratic, clinically apparent liver injury.

### Background

Guselkumab (gue" sel koo' mab) is a human monoclonal immunoglobulin G1 antibody to interleukin (IL)-23, a cytokine that is an important mediator of autoimmune reactions. IL-23 is found in the skin lesions of psoriasis and in the affected gastrointestinal mucosa of patients with inflammatory bowel disease. Although similar, guselkumab is directed to the p19 subunit of IL-23 whereas ustekinumab is directed at the p40 subunit which is a component shared by both IL-23 and IL-12. As a consequence, guselkumab has a more restricted activity in the Th17 immune pathways which are considered to play a major role in autoimmune reactions. Guselkumab was approved for use in United States in 2017, and current indications are limited to moderate-to-severe plaque psoriasis, although it is under active investigation as therapy of several other autoimmune diseases. Guselkumab is available in liquid solution in single use prefilled syringes of 100 mg/mL under the brand name Tremfya. The typical regimen is 100 mg subcutaneously initially, 4 weeks later and then every 8 weeks. Side effects are uncommon and are usually mild, but may include injection site reactions, headache, arthralgias, diarrhea, gastroenteritis, and minor infections such as upper respiratory infections and those due to tinea and herpes simplex. Less common, but potentially severe side effects include serious infections and reactivation of tuberculosis.

### Hepatotoxicity

Mild-to-moderate serum aminotransferase elevations were reported to occur in 2.6% of patients during guselkumab therapy compared to 1.9% of placebo controls. The elevations, however, were self-limited and resolved even with continuing cyclic therapy and did not require discontinuation. Neither during premarketing evaluation nor subsequently have there been case reports of clinically apparent, acute liver injury with symptoms or jaundice linked to guselkumab therapy, but experience with its use has been limited. Guselkumab has immunosuppressive activity but has not been linked to instances of reactivation of hepatitis B or worsening of hepatitis C. However, patients at risk for these complications are often excluded from preregistration clinical trials and ustekinumab, a similar biologic agent, has been shown to cause reactivation of hepatitis B in postmarketing studies. HBV reactivation typically occurs in patients with preexisting HBsAg and relatively inactive disease. Reactivation causes acute hepatocellular injury that can be severe and lead to acute liver failure and death or need for emergency liver transplantation. Screening for hepatitis B before starting guselkumab is not recommended in the product label, but screening has been considered “advisable” by academic societies in published guidelines on use of biologics for psoriasis therapy.

Likelihood score: E* (suspected but unproven cause of clinically apparent liver injury, but experience with its use has been limited).

### Mechanism of Liver Injury

The mechanism of possible liver injury due to guselkumab is not known. Reactivation of hepatitis B appears to be due to a brisk immunological response to newly expressed viral antigens caused by suppression of the immune response to hepatitis B antigens. Injury generally arises between courses of immunosuppressive therapy.

### Outcome and Management

Guselkumab has been linked to minor elevations in serum enzymes during therapy but not to clinically apparent liver injury or with reactivation of hepatitis B. The product label for guselkumab does not recommend routine screening for hepatitis B before initiation of therapy. However, guidelines for management of patients who are to receive guselkumab prepared by some academic societies have recommended routine screening before starting treatment. Screening should include tests for HBsAg and anti-HBc (and perhaps also anti-HBs as this may help in management). Prophylaxis with a potent oral, antiviral agent effective against hepatitis B is recommended for persons who have HBsAg in serum. An alternative approach is careful monitoring for HBV DNA during therapy and early institution of antiviral therapy if levels rise.

Drug Class: Dermatologic Agents, Psoriasis Agents; Monoclonal Antibodies

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Guselkumab – Tremfya®

DRUG CLASS

Dermatologic Agents, Psoriasis Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Guselkumab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Guselkumab | 1350289-85-8 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 26 June 2018

Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 569-91. (Review of hepatotoxicity of immunosuppressive agents; does not mention guselkumab specifically but discusses the problems of reactivation of hepatitis B and states that "the biological immunosuppressants are largely free from hepatotoxicity, with the exception of the TNF alpha antagonists").
Chabner BA, Barnes J, Neal J, Olson E, Mujagiv H, Sequist L, Wilson W, et al. Targeted therapies: tyrosine kinase inhibitors, monoclonal antibodies, and cytokines. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1731-53. (Textbook of pharmacology and therapeutics).
Leonardi CL, Kimball AB, Papp KA, Yeilding N, Guzzo C, Wang Y, Li S, et al.; PHOENIX 1 study investigators. Efficacy and safety of ustekinumab, a human interleukin-12/23 monoclonal antibody, in patients with psoriasis: 76-week results from a randomised, double-blind, placebo-controlled trial (PHOENIX 1). Lancet 2008; 371 (9625): 1665-74. (Among 766 patients with psoriasis treated with 1 of 2 doses of ustekinumab or placebo for 12 weeks, response rates were 67% and 66% with ustekinumab vs 3% with placebo, and side effects were similar and "results of laboratory results were much the same" in the 3 groups). 18486739
Papp KA, Langley RG, Lebwohl M, Krueger GG, Szapary P, Yeilding N, Guzzo C, et al.; PHOENIX 2 study investigators. Efficacy and safety of ustekinumab, a human interleukin-12/23 monoclonal antibody, in patients with psoriasis: 52-week results from a randomised, double-blind, placebo-controlled trial (PHOENIX 2). Lancet 2008; 371 (9625): 1675-84. (Among 1230 patients with psoriasis treated for 12 weeks with 1 of 2 doses of ustekinumab or placebo, clinical response rates were 67% and 76% with ustekinumab vs 4% with placebo, and "rates of laboratory abnormalities were similar between groups, and no differences were noted in liver aminotransferase concentrations"). 18486740
Gottlieb A, Menter A, Mendelsohn A, Shen YK, Li S, Guzzo C, Fretzin S, et al. Ustekinumab, a human interleukin 12/23 monoclonal antibody, for psoriatic arthritis: randomised, double-blind, placebo-controlled, crossover trial. Lancet 2009; 373 (9664): 633-40. (Among 146 patients with psoriatic arthritis treated with either ustekinumab or placebo, responses at week 12 were more frequent with ustekinumab [42% vs 10%] and, while overall rates of adverse events were similar [61% vs 63%], ALT elevations occurred in 4% of ustekinumab vs 1% of placebo recipients). 19217154
Griffiths CE, Strober BE, van de Kerkhof P, Ho V, Fidelus-Gort R, Yeilding N, Guzzo C, et al.; ACCEPT Study Group. Comparison of ustekinumab and etanercept for moderate-to-severe psoriasis. N Engl J Med 2010; 362: 118-28. (Among 903 patients with psoriasis treated with 1 of 2 doses of ustekinumab vs etanercept for 12 weeks, clinical response rates were higher with ustekinumab [68-74% vs 57%], while rates of ALT elevations were similar [0.5-0.9% vs 1.2%]). 20071701
Opel D, Economidi A, Chan D, Wasfi Y, Mistry S, Vergou T, Antoniou C, Sofen H. Two cases of hepatitis B in patients with moderate to severe psoriasis with ustekinumab. J Drugs Dermatol 2012; 11: 1498-501. (Two men, 33 and 40 years old, with severe psoriasis developed acute hepatitis B during ustekinumab therapy and recovered with clearance of HBsAg). 23377523
Chiu HY, Chen CH, Wu MS, Cheng YP, Tsai TF. The safety profile of ustekinumab in the treatment of patients with psoriasis and concurrent hepatitis B or C. Br J Dermatol 2013; 169: 1295-303. (Among 18 patients with psoriasis and concurrent hepatitis B or C, reactivation of HBV occurred in 2 of 11 with HBsAg, but with a rise in HBV DNA levels only, without symptoms or ALT elevations, while reactivation of HCV occurred in 1 of 4 patients marked by a rise in HCV RNA without change in ALT). 23746170
Motaparthi K, Stanisic V, Van Voorhees AS, Lebwohl MG, Hsu S; Medical Board of the National Psoriasis Foundation. From the Medical Board of the National Psoriasis Foundation: Recommendations for screening for hepatitis B infection prior to initiating anti-tumor necrosis factor-alfa inhibitors or other immunosuppressive agents in patients with psoriasis. J Am Acad Dermatol 2014; 70: 178-86. (Mentions that little is known about the effects of ustekinumab on HBV infection, but that screening for hepatitis B markers is "advisable" before its use). 24220724
Sofen H, Smith S, Matheson RT, Leonardi CL, Calderon C, Brodmerkel C, Li K, et al. Guselkumab (an IL-23-specific mAb) demonstrates clinical and molecular response in patients with moderate-to-severe psoriasis. J Allergy Clin Immunol 2014; 133: 1032-40. (Among 24 patients with moderate-to-severe psoriasis treated with a single dose of guselkumab [10, 30, 100 or 300 mg] or placebo, clinical responses occurred in 60% to 100% of those given the higher doses but in no placebo recipient; the adverse events were similar in the 5 groups and there were no serious adverse events). 24679469
Gordon KB, Duffin KC, Bissonnette R, Prinz JC, Wasfi Y, Li S, Shen YK, et al. A phase 2 trial of guselkumab versus adalimumab for plaque psoriasis. N Engl J Med 2015; 373: 136-44. (Among 293 patients with moderate-to-severe plaque psoriasis treated with one of 5 regimens of guselkumab vs placebo or adalimumab for 16 weeks, clinical improvements were greater with higher doses of guselkumab while rates of adverse events were similar). 26154787
Blauvelt A, Papp KA, Griffiths CE, Randazzo B, Wasfi Y, Shen YK, Li S, et al. Efficacy and safety of guselkumab, an anti-interleukin-23 monoclonal antibody, compared with adalimumab for the continuous treatment of patients with moderate to severe psoriasis: Results from the phase III, double-blinded, placebo- and active comparator-controlled VOYAGE 1 trial. J Am Acad Dermatol 2017; 76: 405-17. (Among 837 patients with psoriasis treated with guselkumab [329], placebo [174] or adalimumab [334], clinical responses were more frequent with guselkumab [85%] than placebo [7%] or adalimumab [66%], while adverse event rates were similar; no mention of ALT elevations or hepatotoxicity). 28057360
Reich K, Armstrong AW, Foley P, Song M, Wasfi Y, Randazzo B, Li S, et al. Efficacy and safety of guselkumab, an anti-interleukin-23 monoclonal antibody, compared with adalimumab for the treatment of patients with moderate to severe psoriasis with randomized withdrawal and retreatment: Results from the phase III, double-blind, placebo- and active comparator-controlled VOYAGE 2 trial. J Am Acad Dermatol 2017; 76 (3): 418-31. (Among 992 patients with psoriasis treated with guselkumab [496], placebo [280] or adalimumab [248], clinical responses were more frequent with guselkumab [84%] than placebo [9%] or adalimumab, while adverse event rates were similar and 1% of both treated groups developed a serious infection; no mention of ALT elevations or hepatotoxicity). 28057361
Langley RG, Tsai TF, Flavin S, Song M, Randazzo B, Wasfi Y, Jiang J, et al. Efficacy and safety of guselkumab in patients with psoriasis who have an inadequate response to ustekinumab: Results of the randomized, double-blind, Phase 3 NAVIGATE trial. Br J Dermatol 2018; 178: 114-23. (Among 268 patients with psoriasis who had an inadequate response to a 16-week course of ustekinumab, response rates after 52 weeks were greater in those who switched to guselkumab [36%] than in those who remained on ustekinumab [17%], while adverse events were more frequent with guselkumab [64% vs 56%] including infections requiring antibiotics [16% vs 10%]; no mention of ALT elevations or hepatotoxicity). 28635018
Nakamura M, Lee K, Jeon C, Sekhon S, Afifi L, Yan D, Lee K, et al. Guselkumab for the treatment of psoriasis: a review of phase III trials. Dermatol Ther (Heidelb) 2017; 7: 281-92. (Summary of results of 2 phase III randomized controlled trials of guselkumab in psoriasis [Blauvent 2017, Reich 2017]; no mention of ALT elevations or hepatotoxicity). 28639011
Smolen JS, Agarwal SK, Ilivanova E, Xu XL, Miao Y, Zhuang Y, Nnane I, et al. A randomised phase II study valuating the efficacy and safety of subcutaneously administered ustekinumab and guselkumab in patients with active rheumatoid arthritis despite treatment with methotrexate. Ann Rheum Dis 2017; 76: 831-9. (Among 274 patients with rheumatoid arthritis and an inadequate response to methotrexate, response rates were similar at week 28 after adding guselkumab [41%], ustekinumab [54%] or placebo [40%], while adverse event rates were similar in the 3 groups and serious infections were rare [~1%] in both groups treated with biologics). 28087506
Guselkumab (Tremfya) for psoriasis. Med Lett Drugs Ther 2017; 59 (1533): 179-80. (Concise review of the mechanism of action, clinical efficacy, safety and costs of guselkumab shortly after its approval as therapy of psoriasis in the US; mentions that hepatic enzyme elevations occurred in 2.6% of patients compared to 1.9% of controls and that reactivation of tuberculosis has been reported with its use). 29125591
Deodhar A, Gottlieb AB, Boehncke WH, Dong B, Wang Y, Zhuang Y, Barchuk W, CNTO1959PSA2001 Study Group. Efficacy and safety of guselkumab in patients with active psoriatic arthritis: a randomised, double-blind, placebo-controlled, phase 2 study. Lancet 2018; 391 (10136): 2213-24. (Among 149 patients with psoriatic arthritis treated with guselkumab or placebo for 24 weeks, clinical responses were more frequent with guselkumab and side effects were mild, ALT elevations occurring in 9% vs 1%, although none were associated with symptoms or jaundice and none required early discontinuation of treatment). 29893222
Terui T, Kobayashi S, Okubo Y, Murakami M, Hirose K, Kubo H. Efficacy and safety of guselkumab, an anti-interleukin 23 monoclonal antibody, for palmoplantar pustulosis: a randomized clinical trial. JAMA Dermatol 2018; 154: 309-16. (Among 49 patients with palmoplantar pustulosis treated with guselkumab or placebo in a 24 week trial, severity index scores improved more with guselkumab than placebo, while adverse event rates were similar and changes in “laboratory values were not clinically relevant). 29417135

## OTHER REFERENCE LINKS

1. Recent References on Guselkumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(theophylline/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Guselkumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=theophylline)